# Mahogany Seed

## OVERVIEW

### Introduction

Mahogany, Swietenia macrophylla, is a lofty fruit-bearing tree native to tropical areas of the Americas that is a valuable source of timber and also of herbal products made from its seeds, fruit (Skyfruit), leaves, stems, or bark. Recently, extracts of mahogany seeds have been reported to cause clinically apparent acute liver injury.

### Background

Mahogany (Swietenia macrophylla and other species) is a lofty, fruit-bearing tree native to tropical areas of the Americas including Florida, Mexico, Central and South America, that is widely used for its valuable timber but also for herbal products made from extracts of its fruit, seeds, leaves, stems, and bark. Extracts of mahogany seeds (from Swietenia macrophylla, humulis, and mahagoni) have been used in traditional Indian, South Asian and Chinese medicine as therapy of a variety of conditions, including diabetes, hypertension, viral and parasitic infections, and pain. Studies in cell culture and animal models suggest that these extracts have hypoglycemic, antiinflammatory, antihypertensive, analgesic, antiviral and even antineoplastic activities, but none of these biologic actions has been demonstrated in humans. Phytochemical analyses of extracts demonstrate over 50 different limonoids such as swietenine, swietenolide, augustineolide, andirobin, swietemahonins, swietenitins, and proceranolide. Mahogany extracts also have multiple steroids, fatty acid esters, polyphenols (catechins), essential oils, coumarin and lignan. The biologically active component(s) of mahogany fruit and seed extracts are unknown but suspected to be limonoids. Various forms of mahogany seed are available either as the raw seeds or an extract, alone or combined with other herbs and nutritional agents in multi-ingredient dietary products. It is generally used to treat hypertension and diabetes, but also to improve wellness and energy. There is little information about common side effects of mahogany seed extracts in humans.

### Hepatotoxicity

Mahogany seed extracts have not been subjected to prospective trials of their safety and efficacy, but they are widely described in traditional medicine as being well tolerated and without side effects. Nevertheless, there have been a small number of reports from China, India, and South Asia of clinically apparent liver injury attributed to Mahogany seeds or their extracts. The latency to onset was typically 1 to 2 months but ranged from a week to as long as 6 months, presenting with symptoms of fatigue, nausea, poor appetite, dark urine, and jaundice. In published cases, the liver injury has been hepatocellular, and immune allergic reactions (fever, rash) were not common. In some instances, low levels of autoantibodies were found but immunoglobulins were typically normal and liver biopsies were more suggestive of drug induced liver injury than autoimmune hepatitis. Severity in published cases ranged from mild and asymptomatic elevations in serum aminotransferase levels to clinically apparent hepatitis and even severe hepatitis with signs of hepatic failure. Recovery was rapid once the herbal product was stopped and complete within 1 to 3 months with or without corticosteroid therapy. There have been no reports of chronicity.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism and the ingredient in mahogany seeds responsible for the liver injury have not been identified. The most characteristic ingredients are the limonoids such as swietenine which has been studied in animal models for effects of blood glucose and other metabolic factors.

### Outcome and Management

Cases of liver injury from mahogany seed have ranged in severity from minimally symptomatic elevations in serum aminotransferase levels to cases of mild hepatitis resolving rapidly upon stopping, to severe hepatitis with symptoms and signs of acute liver failure. Liver injury from mahogany seed is typically hepatocellular but self-limited in course and chronic injury has not been well described. Corticosteroids have been used in some cases but with unclear benefit. Cases of rechallenge have not been reported but it should be avoided.

Drug Class: Herbal and Dietary Supplements

Other names: Skyfruit, Swietenine, Large Leaf Mahogany

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mahogany Seed – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Swietenine | 4801-97-2 | C32-H40-O9 | Not Available
Swietenolide | 3776-48-5 | C27-H34-O8 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 01 October 2024

Abbreviations: DILI, drug-induced liver injury; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not mahogany seed).
Dewanjee S, Maiti A, Das AK, Mandal SC, Dey SP. Swietenine: a potential oral hypoglycemic from Swietenia macrophylla seed. Fitoterapia. 2009;80:249-51. (Assessment of the hypoglycemic effects of an extract of mahogany seeds [swietenine] demonstrated reduction in fasting blood glucose in a streptozocin-treated rat model of diabetes). 19239921
Moghadamtousi SZ, Goh BH, Chan CK, Shabab T, Kadir HA. Biological activities and phytochemicals of Swietenia macrophylla King. Molecules. 2013;18:10465-83. (Phytochemical analysis of the components found in extracts from Swietenia macrophylla [Mahogany tree] demonstrated multiple limonoids including swietenine and related compounds as well as steroids, fatty acid esters, polyphenols, essential oils, coumarin, and lignan, with a summary of the various biologic activities described in in vivo studies). 23999722
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention mahogany seed). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal, and traditional herbal remedies; no mention of mahogany seed). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to mahogany seed). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss mahogany seed). 27402097
Ch'ng YS, Loh YC, Tan CS, Ahmad M, Asmawi MZ, Wan Omar WM, Yam MF. Vasodilation and antihypertensive activities of Swietenia macrophylla (Mahogany) seed extract. J Med Food. 2018;21:289-301. (Ethanolic extracts of mahogany seeds decreased systolic and diastolic blood pressure in a spontaneous hypertensive rat model and led to vasodilation in assays using rat thoracic aortic rings). 29420109
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of mahogany seed). 29307848
Yeap V, Tan TJY, Loh T, Kumar R. Liver failure associated with mahogany seed extract consumption. BMJ Case Rep. 2018;2018:bcr2018225382. (45 year old Indian woman developed fatigue, nausea, dark urine and jaundice 6 months after starting a Swietenia mahagoni seed [Skyfruit] extract [bilirubin 15.1 mg/dL, ALT 1267 U/L, Alk P 124 U/L, protime 16.8 sec], biopsy showing hepatitis with bridging necrosis, with rapid recovery upon stopping). 30061133
Tan Y, Chen H, Zhou X, Sun L. RUCAM-based assessment of liver injury by xiang-tian-guo (Swietenia macrophylla) seeds, a plant used for treatment of hypertension and diabetes. Ann Hepatol. 2019;18:406-407. (Brief report from China of 3 elderly male patients who developed liver injury 1-2 months after starting mahogany seeds [1 raw Swietenia macrophylla seed three times daily], one with jaundice [bilirubin 12.4 mg/dL, ALT 678 U/L, Alk P 254], resolving 8 weeks after stopping and the other two without jaundice [ALT 363 and 224 U/L, Alk P 122 and 108 U/L], resolving within 4 and 2 weeks of stopping). 31056362
Sukardiman, Ervina M. The recent use of Swietenia mahagoni (L.) Jacq. as antidiabetes type 2 phytomedicine: A systematic review. Heliyon. 2020;6:e03536. (Review of the phytochemistry and in vitro and in vivo evidence of antidiabetic activity of several species of Swietenia, including mahagoni [West Indies], humilis [Pacific Coast], and macrophylla [Honduran]; no discussion of clinical studies in humans or hepatotoxicity). 32190758
Xia C, Liu Y, Yao H, Zhu W, Ding J, Jin J. Causality assessment of skyfruit-induced liver injury using the updated RUCAM: a case report and review of the literature. J Int Med Res. 2020;48:300060520917569. (63 year old woman developed epigastric pain, nausea, and fever a week after taking 3 Skyfruit seeds daily for 3 days [bilirubin 1.3 mg/dL, ALT 466 U/L, Alk P 104 U/L], with rapid resolution within the following month; review of the literature mentions 7 cases, 2 reported in Chinese). 32293220
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; mahogany seed is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; mahogany seed is not mentioned). 33434654

## OTHER REFERENCE LINKS

1. Recent References on Mahogany seed or Swietenine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mahogany+seed%20or%20Swietenine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Mahogany seed or Swietenine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mahogany%20seed%20OR%20Swietenine)